# Delafloxacin

## OVERVIEW

### Introduction

Delafloxacin is a fourth generation fluoroquinolone with expanded activity against gram-positive bacteria as well as atypical pathogens. Delafloxacin has been linked to mild ALT elevations during therapy, but has yet to be linked to instances of idiosyncratic acute liver injury with symptoms and jaundice as have been described with other fluoroquinolones.

### Background

Delafloxacin (del" a flox' a sin) is a fourth generation fluoroquinolone with expanded activity against gram-positive bacteria including multidrug resistant strains of Streptococcus pneumoniae. Like other fluoroquinolones, delafloxacin is active against a wide range of aerobic gram-positive and gram-negative organisms. The quinolones are believed to act by inhibition of bacterial DNA gyrase and topoisomerase IV that are required for synthesis of bacterial mRNAs (transcription) and DNA replication. In contrast, DNA gyrases are not present in human [and other eukarotic] cells and the equivalent topoisomerases are not sensitive to fluoroquinolone inhibition. Delafloxacin was approved for use in the United States in 2018 and is available under the commercial name Baxdela. Current indications are limited to skin and skin structure infections due to sensitive organisms. Delafloxacin is available in both oral and parenteral formulations as 450 mg tablets and as 300 mg of a lyophilized powder in a single dose vial for reconstitution. The recommended regimen is an oral dose of 450 mg every 12 hours or by intravenous infusion every 12 hours for 5 to 14 days. Common side effects include gastrointestinal upset, nausea, diarrhea, headache, skin rash and allergic reactions. Less common, but more severe side effects of delafloxacin that are shared by other fluoroquinolones include seizures, hallucinations, peripheral neuropathy, tendon rupture, severe hypersensitivity reactions, Stevens Johnson syndrome, angioedema, photosensitivity and Clostridium difficile-associated diarrhea.

### Hepatotoxicity

Delafloxacin, like other fluoroquinolones, is associated with a low rate (3% to 4%) of serum enzyme elevations during therapy. These abnormalities are generally mild, asymptomatic and transient, resolving even with continuation of therapy. ALT elevations above 5 times the upper limit of normal occur in 1% or less of subjects. Although delafloxacin may not have been clearly linked to cases of clinically apparent liver injury, the other fluoroquinolones, such as ciprofloxacin, levofloxacin and moxifloxacin, rank among the 25 most common causes of drug induced liver injury in many case series. Estimates of the frequency of liver injury from fluoroquinolones have been 1:15,000 to 1:25,000 exposed persons. Delafloxacin has been in clinical use for a short time only, but is likely to have a similar frequency and pattern of liver injury as the other fluoroquinolones.

The typical presentation of fluoroquinolone associated liver injury is with a short latency (1 day to 3 weeks) and abrupt onset with nausea, fatigue, abdominal pain and jaundice. The pattern of serum enzyme elevations can be either hepatocellular or cholestatic, cases with the shorter times to onset usually being more hepatocellular. In addition, the onset of illness may occur a few days after the medication is stopped. Many (but not all) cases have prominent allergic manifestations with fever and rash, and the liver injury may occur in the context of a generalized hypersensitivity reaction. Autoantibodies are usually not present. Most reported cases of liver injury from fluoroquinolones have been mild and self-limited, with recovery in 4 to 8 weeks from onset. However, the fatality rate of cases with jaundice has been greater than 10%. In addition, cases with a cholestatic pattern of serum enzymes may run a prolonged course and, in rare instances, have progressed to chronic vanishing bile duct syndrome leading to liver failure. Nevertheless, delafloxacin is a relatively recently introduced antibiotic and has yet to be convincingly linked to instances of acute hepatitis or jaundice.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from the fluoroquinolones is unknown but appears to be hypersensitivity.

### Outcome and Management

Mild-to-moderate injury from fluoroquinolone induced hepatitis should be followed by full recovery within 4 to 8 weeks. Cases of acute liver failure with death or need for liver transplantation have been reported, nor have chronic cases with bile duct loss. Cross reactivity of the hepatic injury between different fluoroquinolones has not been demonstrated but is suspected based upon the similarity of clinical patterns of injury and latency. Thus, patients who developed clinically apparent liver injury from a fluoroquinolone should be advised to avoid delafloxacin. Monitoring of liver tests during therapy is likely to be ineffective as the typical course of treatment is only 5 to 10 days.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Fluoroquinolones: Ciprofloxacin, Gemifloxacin, Levofloxacin, Moxifloxacin, Norfloxacin, Ofloxacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Delafloxacin – Baxdela®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=fb77637a-88d9-4aea-958f-e270030ce30d)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Delafloxacin Meglumine | 352458-37-8 | C18-H12-Cl-F3-N4-O4.C7-H17-N-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2020

Zimmerman HJ. Quinolones. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p 603. (Expert review of hepatotoxicity published in 1999; mentions that cinoxacin, nalidixic acid, ciprofloxacin, norfloxacin, enoxacin, and ofloxacin are associated with minor serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury; delafloxacin is not discussed).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics; mentions that hepatocellular and cholestatic forms of injury have been reported due to the fluoroquinolones including cases of ductopenia, acute liver failure and death).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1015-8. (Textbook of pharmacology and therapeutics).
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH, DILIN Research Group. (2011). Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol. (Among 679 cases of drug induced liver injury presenting between 2004 and 2010 at 8 US medical centers, 12 [1.8%] were attributed to fluoroquinolones including 6 cipro-, 4 moxi-, 1 levo-, and 1 gatifloxacin; the average time to onset was 4 days [range 1-39], with both hepatocellular and cholestatic enzyme patterns, 7 with rash or fever, mortality was limited to those with hepatocellular injury and jaundice; hepatic injury was class specific; moxifloxacin cases included 3 men, 1 woman, ages 45-71 years, onset after 1-7 days, 1 with fever and 2 with rash [bilirubin 0.9-5.3 mg/dL, ALT 220-1311 U/L, Alk P 253-837 U/L], 1 patient developed vanishing bile duct syndrome and underwent liver transplantation: Case 1).
Paterson JM, Mamdani MM, Manno M, Juurlink DN, Canadian Drug Safety and Effectiveness Research Network. (2012). Fluoroquinolone therapy and idiosyncratic acute liver injury: a population-based study. CMAJ. (Population based, case control study of antibiotic exposure and subsequent hospitalization for liver injury within 30 days in elderly Canadian outpatients found weak associations with ciprofloxacin [adjusted odds ratio 1.56]), levofloxacin [2.06] and moxifloxacin [2.44], but not clarithromycin or cefuroxime).
Hayashi PH, Chalasani NP. (2012). Liver injury in the elderly due to fluoroquinolones: should these drugs be avoided?. CMAJ. (Editorial in response to Paterson [2012] stressing the low absolute risk of liver injury from the fluoroquinolones [4-9 per 100,000 exposures]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 26 due to antibiotics, but none were attributed to fluoroquinolones).
Alshammari TM, Larrat EP, Morrill HJ, Caffrey AR, Quilliam BJ, LaPlante KL. (2014). Risk of hepatotoxicity associated with fluoroquinolones: a national case-control safety study. Am J Health Syst Pharm. (Retrospective analysis of Veterans Affairs patients receiving a fluoroquinolone [n=7862] found a higher relative risk of developing acute liver injury after receipt of ciprofloxacin compared to matched controls [adjusted odds ratio: OR=1.29], but not after receipt of levofloxacin [OR=1.16) or moxifloxacin [OR=0.98]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 38 cases [4%] were attributed to fluoroquinolones, including 16 due to ciprofloxacin [the 8th most common prescription drug cause], 13 due to levofloxacin and 8 to moxifloxacin).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, Ghabril MS, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, of whom 94% developed evidence of chronic liver injury suggestive of vanishing bile duct syndrome, 2 of which were due to fluoroquinolones, 1 moxifloxacin and 1 levofloxacin).
O'Riordan W, Mehra P, Manos P, Kingsley J, Lawrence L, Cammarata S. (2015). A randomized phase 2 study comparing two doses of delafloxacin with tigecycline in adults with complicated skin and skin-structure infections. Int J Infect Dis. (Among 150 patients with complicated skin or skin structure infections treated with 1 of 2 doses of delafloxacin or tigercycline for 5-14 days, clinical efficacy and adverse event rates were similar; ALT elevations occurring in 3% of delafloxacin, but in none of tigecycline treated subjects).
Pullman J, Gardovskis J, Farley B, Sun E, Quintas M, Lawrence L, Ling R, et al., PROCEED Study Group. (2017). Efficacy and safety of delafloxacin compared with vancomycin plus aztreonam for acute bacterial skin and skin structure infections: A Phase 3, double-blind, randomized study. J Antimicrob Chemother. (Among 660 patients with acute bacterial skin or skin structure infections treated with delafloxacin or the combination of vancomycin and aztreonam, clinical response and adverse event rates were similar, ALT elevations above 5 times ULN occurred in 0.9% vs 1.5% of subjects, and no patient developed clinically apparent liver injury with jaundice).
Markham A. (2017). Delafloxacin: first global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of delafloxacin; mentions that aminotransferase elevations occur in 3-4% of treated patients, but cases of clinically apparent liver injury with jaundice were not observed in the prelicensure studies).
(2018). Delafloxacin (Baxdela)--a new fluoroquinolone antibiotic. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of delafloxacin shortly after its approval for use in the US; mentions adverse side effects of aminotransferase elevations [3%] and that it, like other fluoroquinolones, has a boxed warning about tendinitis, tendon rupture, peripheral neuropathy and CNS effects, and that it can also lead to C. difficile diarrhea).
O'Riordan W, McManus A, Teras J, Poromanski I, Cruz-Saldariagga M, Quintas M, Lawrence L, et al., PROCEED Study Group. (2018). A comparison of the efficacy and safety of intravenous followed by oral delafloxacin with vancomycin plus aztreonam for the treatment of acute bacterial skin and skin structure infections: a phase 3, multinational, double-blind, randomized study. Clin Infect Dis. (Among 850 patients with acute bacterial skin or skin structure infections treated with delafloxacin or the combination of vancomycin and aztreonam for 5-14 days, clinical efficacy and overall adverse event rates were similar in the two groups, no patient developed clinically apparent liver injury with jaundice and ALT elevations above 5 times ULN occurred in 1.2% vs 1.9% of subjects).
(2018). Comparison table: some systemic fluoroquinolones. Med Lett Drugs Ther. (Table comparing 4 fluoroquinolones [cipro-, levo-, dela- and moxifloxacin] mentions that ALT and AST elevations are a class adverse event).
Mavros MN, Theochari NA, Kyriakidou M, Economopoulos KP, Sava JA, Falagas ME. (2019). Fluoroquinolone-based versus β-lactam-based regimens for complicated intra-abdominal infections: a meta-analysis of randomised controlled trials. Int J Antimicrob Agents. (Systematic review of controlled trials of fluoroquinolones versus β-lactam-based antibiotic regimens found similar rates of efficacy and adverse events; no discussion of ALT elevations or liver related toxicities).
Kuula LSM, Viljemaa KM, Backman JT, Blom M. (2019). Fluoroquinolone-related adverse events resulting in health service use and costs: A systematic review. PLoS One. (Systematic review of observational studies on safety of fluoroquinolones concluded that due to lack of published literature, health service and costs could not be evaluated).

## OTHER REFERENCE LINKS

1 Recent References on Delafloxacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Delafloxacin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Delafloxacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Delafloxacin)